# Rofecoxib

## OVERVIEW

### Introduction

Rofecoxib is a nonsteroidal antiinflammatory drug (NSAID) that selectively inhibits cyclooxgenase-2 (Cox-2), which was used in the therapy of chronic arthritis and mild-to-moderate musculoskeletal pain. Rofecoxib was withdrawn in 2004 because of an association with an increase in cardiovascular events with its long term use. Rofecoxib had also been linked transient serum aminotransferase elevations during therapy and to rare instances of idiosyncratic drug induced liver disease.

### Background

Rofecoxib (roe" fe kox' ib) is a nonsteroidal antiinflammatory drug that acts through selective inhibition of cyclooxgenase-2 resulting in decreased prostaglandin synthesis and thereby decreasing inflammation, fever and pain. The specificity for Cox-2 is believed to make rofecoxib less likely to cause gastrointestinal mucosal injury compared to standard NSAIDs that inhibit both Cox-1 and Cox-2 enzymes. Rofecoxib was approved for use as therapy of chronic arthritis due to osteoarthritis, rheumatoid arthritis and ankylosing spondylitis, as well as for acute pain from musculoskeletal conditions and trauma and for primary dysmenorrheal in 1998. Subsequently, large scale prospective studies suggested that use of rofecoxib was associated with an increased rate of cardiovascular and cerebrovascular events, and the drug was withdrawn in September 2004. Rofecoxib was previously available by prescription as capsules of 12.5 and 25 mg under the commercial name Vioxx and was given in several week courses for acute pain or trauma and long term for chronic arthritis. The typically recommended dose was 12.5 to 25 mg once daily. As with other NSAIDs, rofecoxib is generally well tolerated, but side effects can include headache, dizziness, somnolence, dyspepsia, abdominal discomfort, diarrhea, peripheral edema and hypersensitivity reactions. Rare but serious adverse events from NSAIDs include gastrointestinal ulceration and bleeding, increased risk for cardiovascular disease, renal dysfunction and hypersensitivity reactions including anaphylaxis, exfoliative dermatitis and Stevens Johnson syndrome.

### Hepatotoxicity

In clinical studies involving several thousand patients treated for at least 3 months, the rate of serum aminotransferase enzyme elevations above three times the upper limit of the normal range was 1.8% in rofecoxib treated compared to 0.3% in placebo treated patients and 0.1-0.4% in patients receiving other common NSAIDs. Thus, ALT elevations due to rofecoxib were uncommon and usually of minimal clinical significance, resolving even with drug continuation.

In rare instances, rofecoxib can cause clinically apparent, symptomatic drug induced liver injury with jaundice. The pattern of liver enzyme elevations has usually been cholestatic or mixed (Case 1), although hepatocellular patterns of injury have also been described. The latency to onset of liver injury was extremely variable, ranging from a few weeks to several years, but was typically within 1 to 12 weeks of starting. Autoimmune and immunoallergic features were uncommon.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of acute hepatic injury from rofecoxib is unknown. The clinical pattern of injury resembles that of other NSAID induced liver injury.

### Outcome and Management

The idiosyncratic liver injury due to rofecoxib can lead to prolonged jaundice, but has not been associated with acute liver failure or vanishing bile duct syndrome. In the few cases that have been described, the time to recovery has varied greatly, but is usually 1 to 3 months. Rechallenge should be avoided, but there is little information to suggest that there is cross reactivity with other NSAIDs.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORT

### Case 1. Acute hepatocellular injury with jaundice due to rofecoxib.(1).

A 76 year old woman developed jaundice and pruritus 22 months after starting rofecoxib (25 mg daily) for osteoarthritis. She had no history of liver disease, alcohol abuse, drug allergies or risk factors for viral hepatitis. Her other medical condition included polymyalgia rheumatica for which she took prednisone (3 mg daily) and hypothyroidism for which she took levothyroxine (72 mcg daily). She took multivitamins, but no other over-the-counter or herbal medications. On examination, she was jaundiced and had mild hepatic tenderness, but no fever, rash, lymphadenopathy or signs of chronic liver disease. She was admitted for evaluation and rofecoxib was discontinued. Laboratory tests showed a total bilirubin of 5.6 mg/dL with a direct fraction of 5.2 mg/dL and modest elevations in aminotransferase and alkaline phosphatase levels (Table). Tests for viral hepatitis and autoimmune liver disease were negative. Imaging of the abdomen and liver were normal without evidence of biliary obstruction. Her jaundice and pruritus worsened. Magnetic resonance and endoscopic retrograde cholangiopancreatography (ERCP) were done and were normal. A liver biopsy showed intrahepatic cholestasis and mild bile duct damage with mild portal inflammation compatible with a drug induced cholestatic hepatitis. Subsequently, she improved and she was asymptomatic and liver tests were near normal when she was seen approximately 3 months after presentation.

#### Key Points

Medication: | Rofecoxib (25 mg daily)
Pattern: | Mixed-cholestatic (R=2.4)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 22 months
Recovery: | Nearly complete within 3 months
Other medications: | Levothyroxine, prednisone, multivitamins

#### Laboratory Values

Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 239 | 314 | 5.6 | Rofecoxib stopped
2 | 89 | 217 | 12.2 | ERCP normal
4 | Liver biopsy showing intrahepatic cholestasis
~12 | 62 | 187 | 0.8
Normal | <40 | <125 | <1.2

#### Comment

The history and presentation of this case were very typical of a drug induced cholestatic hepatitis and the only medication that could be implicated was rofecoxib which had been taken for 22 months. The latency to onset is atypical, however, but careful evaluation for other causes of obstructive jaundice was unrevealing, and she recovered with stopping the medication. Information of cross sensitivity to other NSAIDs would have been helpful.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rofecoxib – Vioxx®

(Removed from Market Worldwide, 2004)

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rofecoxib | 162011-90-7 | C17-H14-O4-S

## CITED REFERENCE

1 Papachristou GI, Demetris AJ, Rabinovitz M. (2004). Acute cholestatic hepatitis associated with long-term use of rofecoxib. Dig Dis Sci.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 March 2020

Abbreviations: NSAID, nonsteroidal antiinflammatory drugs.

Zimmerman HJ. Nonsteroidal anti-inflammatory drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Expert review of NSAID induced liver injury from 1999; rofecoxib was not discussed).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Expert review of liver injury caused by NSAIDs mentions that rofecoxib can cause serum enzyme elevations and has been linked to rare instances of clinically apparent liver injury).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
McCormick PA, Kennedy F, Curry M, Traynor O. (1999). COX 2 inhibitor and fulminant hepatic failure. Lancet. (Case of ALF due to nimesulide, a Cox-2 inhibitor that was licensed in Europe, but not the US. Symptoms arose at 2 and jaundice at 7 weeks with ALT rising from 187 to 2857 U/L, Alk P from 50 to 114 U/L; patient had liver transplantation, but died of primary graft non-function).
Huster D, Schubert C, Berr F, Mössner J, Caca K. (2002). Rofecoxib-induced cholestatic hepatitis: treatment with molecular adsorbent recycling system (MARS). J Hepatol. (52 year old woman developed jaundice and itching 3 months after starting rofecoxib [bilirubin 24.6 mg/dL, ALT 228 U/L, Alk P 1314 U/L], with prolonged jaundice treated with an extracorporeal liver assist device and ultimately resolving 6 months later).
Harsch IA, Michaeli P, Hahn EG, Konturek PC, Klein R. (2003). A rare case of rofecoxib-induced cholestatic hepatitis. Dig Liver Dis. (73 year old woman developed jaundice and itching 10 days after starting rofecoxib [bilirubin 19.9 mg/dL, ALT 440 U/L, Alk P 435 U/L], positive lymphocyte stimulation test, no information on recovery).
Linares P, Vivas S, Jorquera F, Olcoz JL, de Leon B, Oritz de Urbina J. (2004). Severe cholestasis and acute renal failure related to rofecoxib. Am J Gastroenterol. (74 year old woman developed jaundice 2 months after starting rofecoxib [bilirubin 12.0 rising to 29 mg/dL, ALT 31 U/L, Alk P 2968 U/L], with bloody diarrhea and acute renal failure, ultimately resolving on prednisone, but Alk P elevations were still present 2 years later).
Papachristou GI, Demetris AJ, Rabinovitz M. (2004). Acute cholestatic hepatitis associated with long-term use of rofecoxib. Dig Dis Sci. (76 year old woman developed jaundice and pruritus 22 months after starting rofecoxib [bilirubin 5.6 rising to 12.2 mg/dL, ALT 239 U/L, Alk P 314 U/L], with resolution over next 2-3 months: Case 1).
Rostom A, Goldkind L, Laine L. (2005). Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol. (Systematic review of trials reporting side effects from different NSAIDs: found rate of ALT elevations >3 fold elevated to be 1.8% among 7349 rofecoxib treated persons, higher than placebo recipients [0.29%] and all other NSAIDs [0.04-0.43%] except diclofenac [3.6%]; liver related series adverse events occurred in 0.05%).
Ouar S, Bellaïche G, Belloc J, Tordjman G, Ley G, Slama JL. (2005). Gastroenterol Clin Biol. (69 year old woman developed fatigue 3 days after starting rofecoxib and stopped it promptly, but developed jaundice 1 month later [bilirubin 18.1 mg/dL, ALT 42 times ULN, Alk P 4 times ULN], with severe course and slow recovery over 6 months).
Haider M, Gain E, Khadem G, Pilmore H, Yun K, Jayasinghe N, Walker R. (2005). Simultaneous presentation of rofecoxib-induced acute hepatitis and acute interstitial nephritis. Intern Med J. (62 year old man developed jaundice and itching 5 months after starting rofecoxib [bilirubin 14.0 rising to 29.8 mg/dL, AST 21 U/L, Alk P 218 U/L], with acute interstitial nephritis, ultimately resolving over next 3 months).
Yan B, Leung Y, Urbanski SJ, Myers RP. (2006). Rofecoxib-induced hepatotoxicity: a forgotten complication of the coxibs. Can J Gastroenterol. (Two cases: 44 year old man developed jaundice 2 weeks after restarting rofecoxib [bilirubin 14.1 mg/dL, ALT 1826 U/L, Alk P 741 U/L], resolving in 2 months; 44 year old woman developed jaundice and itching 6 weeks after starting rofecoxib [bilirubin 12.1 mg/dL, ALT 995 U/L, Alk P 243 U/L], resolving in 1-2 months).
Sanchez-Matienzo D, Arana A, Castellsague J, Perez-Gutthann S. (2006). Hepatic disorders in patients treated with COX-2 selective inhibitors or nonselective NSAIDs: a case/noncase analysis of spontaneous reports. Clin Ther. (Industry review of FDA AERS reports of adverse events attributed to NSAIDs: 158,539 reports received, 3% were liver related; highest proportion liver adverse events were reported for sulindac, diclofenac and nimesulide; not for other Cox-2 inhibitors including rofecoxib).
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, Montastruc JL, et al. (2006). Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol. (Compared rates of spontaneous reporting of adverse effects of NSAIDs in Spain and France, found high rate of liver reports [compared to all types] for sulindac [14%] and nimesulide [17%], low for celecoxib [2% of 275 reports] and rofecoxib [0.6% of 499 reports]: 3 cases of liver injury attributed to rofecoxib from Spain and 6 from France 1982-2001).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases and as one of several agents in 3 cases, but none were attributed to rofecoxib).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to rofecoxib).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 62 of which were attributed to NSAIDs but mostly to nimesulide and a few to piroxicam, diclofenac and naproxen, but none to rofecoxib).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, NSAIDs accounted for 28 cases (3%), none of which were attributed to rofecoxib).
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW, Drug-Induced Liver Injury Network (DILIN). (2016). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int. (Among 1221 cases of drug induced liver injury enrolled in a prospective US registry, 30 were attributed to NSAIDs, 30 [2.5%] of which were due to NSAIDs but none were due to rofecoxib).
Bessone F, Hernandez N, Roma MG, Ridruejo E, Mendizabal M, Medina-Cáliz I, Robles-Díaz M, et al. (2016). Hepatotoxicity induced by coxibs: how concerned should we be?. Expert Opin Drug Saf. (Review of the literature and description of clinical features of Cox-2 specific NSAIDs and liver injury mentions 8 cases of rofecoxib related injury, generally presenting as cholestatic hepatitis and resolving within 6 months of onset).
Meunier L, Larrey D. (2018). Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin).

## OTHER REFERENCE LINKS

1 Recent References on Rofecoxib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Rofecoxib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Rofecoxib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rofecoxib)